# Viekira Pak

## OVERVIEW

### Introduction

Viekira Pak is a combination of oral antiviral agents that previously was used to treat chronic hepatitis C, genotype 1. This combination was associated with a low rate of serum enzyme elevations during therapy, and was reported to cause rare cases of clinically apparent liver injury with jaundice and which could result in hepatic decompensation largely in patients with preexisting cirrhosis.

### Background

The hepatitis C virus is a small RNA virus that is a major cause of chronic hepatitis, cirrhosis and hepatocellular carcinoma in the United States as well as worldwide. Various approaches to antiviral therapy of chronic hepatitis C have been developed, starting in the 1980s with interferon alfa which was replaced in the 1990s by long acting forms of interferon (peginterferon), to which was added the oral nucleoside analogue, ribavirin. Between 2010 and 2015, several potent oral, direct acting anti-HCV agents were developed and combinations of these found to have marked activity against the virus, allowing for highly effective and well tolerated therapy without use of interferon and with treatment courses of 8, 12 or 24 weeks only.

Viekira Pak (vee kee' rah pak) is the commercial name for a combination of oral, direct acting antiviral agents used to treat chronic hepatitis C associated with HCV genotype 1. The hepatitis C virus (HCV) encodes several nonstructural (NS) polypeptides that are essential for its replication: NS3/4 that has protease and helicase activities, NS5A that is a membrane bound polypeptide that is essential in the creation of the replicative complex, and NS5B an HCV specific, RNA-dependent, RNA polymerase. These polypeptides are effective targets for antiviral therapy of hepatitis C. Viekira Pak was a combination paritaprevir (par’ i ta’ pre veer: formerly ABT-450) which is a potent HCV NS3/4 protease inhibitor, ombitasvir (om bit’ as veer: ABT-267) an NS5A replication complex inhibitor, and dasabuvir (da sa’ bue veer: ABT-333) a nonnucleoside HCV RNA polymerase [NS5B] inhibitor. Paritaprevir is metabolized by CYP 3A4 and is typically given in combination with low doses of ritonavir, an inhibitor of CYP 3A4, to achieve higher and more prolonged drug levels which allow for once daily dosing. In cell culture and in humans infected with HCV, each of the agents had potent activity against HCV, but development of antiviral resistance rapidly arose with continued exposure. The combination of several direct acting agents with different molecular targets allows for a sustained viral suppression while avoiding antiviral resistance. The combination of these three agents (and ritonavir) with and without ribavirin (an antiviral nucleoside analogue with activity against HCV) has been shown to be very effective in suppressing HCV replication in patients infected with HCV genotype 1, and to result in a sustained virological response (SVR) and eradication of HCV in more than 90% of patients when given for 12 weeks or more. Viekira Pak was approved for use in the United States in 2015, the second all-oral antiviral combination to receive approval for chronic hepatitis C. It was available as two tablets, one being the fixed combination of ombitasvir (12.5 mg), paritaprevir (75 mg) and ritonavir (100 mg) which was given once daily, and the other being dasabuvir (250 mg) which was given twice daily with meals. Ribavirin (if a part of the combination therapy as was recommended for genotype 1a and for patients with cirrhosis) was available in tablets of 200 mg and is given twice daily for a total dose of 1,000 mg (if body weight is <75 kg) or 1,200 mg (if body weight ≥75 kg). The indications for Viekira Pak (the combination of dasabuvir, ombitasvir and paritaprevir with ritonavir: D-O-P/r) were limited to patients with HCV genotype 1. The combination of just ombitasvir and paritaprevir with ritonavir (O-P/r) was also available under the commercial name Technive and was approved for use in combination with ribavirin in patients with chronic hepatitis C, genotype 4, without cirrhosis. Side effects of Viekira Pak and Technive were uncommon, and generally mild including nausea, itching, rash, cough and insomnia. When given with ribavirin, side effects were greater, but are largely due to the hemolysis, nasal congestion and skin reactions that are common with that agent. Viekira Pak and Technive were withdrawn by the sponsor from availability in 2018 when combination therapies with greater efficacy and tolerability became available (such as Mavyret, Epclusa and Zepatier).

### Hepatotoxicity

In large randomized controlled trials, serum aminotransferase elevations more than 5 times the upper limit of normal (ULN) occurred in 1% to 2% of Viekira Pak treated patients. Interestingly, this rate was lower than occurred with placebo therapy (3% to 7%). The elevations were generally asymptomatic and short lived, resolving with or without dose modification and requiring drug discontinuation in approximately 1% of patients. Despite the occurrence of serum enzyme elevations during therapy, clinically apparent liver injury was rarely reported in preregistration studies. However, during the years of its clinical use in the United States and elsewhere, occasional instances of marked serum aminotransferase elevations with symptoms and mild jaundice were reported, although rarely described in the published literature. Furthermore, some patients with chronic hepatitis C and advanced cirrhosis developed sudden hepatic decompensation during therapy with D-O-P/r. Similar episodes have been described in patients receiving other oral antiviral combinations such as sofosbuvir with daclatasvir, ledipasvir or simeprevir. Thus, this phenomenon may be unrelated to a specific agent, but rather common to all potent antiviral therapies for hepatitis C and perhaps is a paradoxical response to sudden clearance of HCV. Alternatively, these episodes may be spontaneous, coincidental and unrelated to the antiviral therapy. Trials of these therapies in patients with cirrhosis were not placebo controlled so that the rate of spontaneous hepatic decompensation in patients with cirrhosis due to hepatitis C is not well defined. Whatever the reason, the occurrence of decompensation in up to 10% of patients with cirrhosis undergoing potent antiviral therapy makes prospective monitoring advisable and prompt discontinuation of treatment if evidence of hepatic failure supervenes.

Thus, the five antiviral compounds included in Viekira Pak regimens (dasabuvir, ombitasvir, paritaprevir, ritonavir and ribavirin) have been linked to instances of sudden ALT elevations during therapy, but uncommonly to clinically apparent liver injury. In patients with preexisting cirrhosis, antiviral therapy with Viekira Pak has been linked to episodes of lactic acidosis and hepatic decompensation. The cause of these sudden, severe adverse events is unknown but they are usually severe and life threatening, requiring prompt discontinuation of treatment, intensive care management and consideration of emergency liver transplantation. These serious adverse effects appear to be less frequent with more recently developed antiviral regimens for hepatitis C and were another reason for the withdrawal of Viekira Pak and Technive.

Likelihood score: B (likely cause of liver injury arising in patients with pre-existing cirrhosis).

### Mechanism of Injury

The mechanism by which Viekira Pak might cause liver injury is not known. The multiple antiviral agents in this combination regimen are metabolized in the liver largely via the cytochrome P450 system, and liver injury may be due to production of a toxic or immunogenic metabolite. Viekira Pak is also susceptible to multiple drug-drug interactions with strong inducers or inhibitors of CYP 3A4, and careful attention to concomitant medications was recommended during use of this regimen.

### Outcome and Management

While therapy with Viekira Pak can be associated with mild-to-moderate serum aminotransferase elevations, it has been only rarely linked to cases of clinically apparent liver injury. Nevertheless, monitoring of serum aminotransferase levels monthly during the first 6 months and every 3 months thereafter was recommended. Patients with preexisting cirrhosis were advised to have close monitoring particularly during the first month of treatment. Viekira Pak should be permanently discontinued if jaundice or symptoms of liver injury arise or if serum ALT or AST levels rise and remain above 5 times the ULN.

Drug Class: Antiviral Agents, Hepatitis C Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Dasabuvir, Ombitasvir, Paritaprevir and Ritonavir – Viekira Pak®

Ombitasvir, Paritaprevir and Ritonavir – Technive®

DRUG CLASS

Hepatitis C Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Viekira%20Pak)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Dasabuvir | 1132935-63-7 | C26-H27-N3-O5-S
Ombitasvir | 1258226-87-7 | C50-H67-N7-O8
Paritaprevir | 1216941-48-8 | C40-H43-N7-O7-S
Ritonavir | 155213-67-5 | C37-H48-N6-O5C37-H48-N6-O5-S2-S2
Ribavirin | 36791-04-5 | C8-H12-N4-O5

## ANNOTATED BIBLIOGRAPHY

References updated: 07 February 2022

Abbreviation used: SVR, sustained virological response.

Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Multi-authored textbook of hepatotoxicity published in 2013 does not discuss oral, direct acting antiviral agents used to treat hepatitis C).
Poordad F, Lawitz E, Kowdley KV, Cohen DE, Podsadecki T, Siggelkow S, Heckaman M, et al. (2013). Exploratory study of oral combination antiviral therapy for hepatitis C. N Engl J Med. (Among 50 patients with chronic hepatitis C, genotype 1, treated with dasabuvir, paritaprevir/ritonavir and ribavirin in varying doses for 12 weeks, the sustained virologic response [SVR] rate was 72%; 1 patient rapidly developed ALT levels above 5 times ULN [308 U/L] without jaundice or symptoms and therapy was stopped at 2 weeks).
DeGoey DA, Randolph JT, Liu D, Pratt J, Hutchins C, Donner P, Krueger AC, et al. (2014). Discovery of ABT-267, a pan-genotypic inhibitor of HCV NS5A. J Med Chem. (Description of identification of an N-phenylpyrrolidine based inhibitor of NS5A, compound 38 [ombitasvir] in screening of HCV replicon systems verified for activity against HCV by phase 1, 3 day studies in 3 patients with chronic hepatitis C, genotype 1).
Kowdley KV, Lawitz E, Poordad F, Cohen DE, Nelson DR, Zeuzem S, Everson GT, et al. (2014). Phase 2b trial of interferon-free therapy for hepatitis C virus genotype 1. N Engl J Med. (Among 571 noncirrhotic patients with chronic hepatitis C, genotype 1, treated with 14 different regimens of D-O-P/r with ribavirin for 8, 12 or 24 weeks, SVR rates ranged from 83% to 100%; side effects included ALT elevations above 5 times ULN [peak 408 U/L] in 5 patients [1%], but all resolved without dose modifications and no patient developed clinically apparent liver injury).
Feld JJ, Kowdley KV, Coakley E, Sigal S, Nelson DR, Crawford D, Weiland O, et al. (2014). Treatment of HCV with ABT-450/r-ombitasvir and dasabuvir with ribavirin. N Engl J Med. (Among 631 patients with noncirrhotic chronic hepatitis C, genotype 1, treated with Viekira Pak [D-O-P/r]) with ribavirin vs all placebos for 12 weeks, SVR rates were 96% vs 0%, and side effects that were more frequent with antiviral therapy were nausea, pruritus, insomnia, diarrhea and weakness, while rates of ALT elevations above 5 times ULN were less common(0.9% vs 4.4%), and no patient developed clinically apparent acute liver injury).
Zeuzem S, Jacobson IM, Baykal T, Marinho RT, Poordad F, Bourlière M, Sulkowski MS, et al. (2014). Retreatment of HCV with ABT-450/r-ombitasvir and dasabuvir with ribavirin. N Engl J Med. (Among 394 previously treated, noncirrhotic patients with chronic hepatitis C, genotype 1, treated with Viekira Pak [D-O-P/r] with ribavirin vs placebos for 12 weeks, the SVR rates were 96% vs 0%; adverse events more frequent with D-O-P/r were fatigue, weakness, insomnia, pruritus, cough and anemia; ALT elevations above 5 times ULN occurred in 5 patients [1.7%] on therapy, one of whom stopped therapy early vs 3 [3.1%] on placebo; no patient developed clinically apparent liver injury).
Ferenci P, Bernstein D, Lalezari J, Cohen D, Luo Y, Cooper C, Tam E, et al. (2014). PEARL-III Study; PEARL-IV Study. ABT-450/r-ombitasvir and dasabuvir with or without ribavirin for HCV. N Engl J Med. (Among 724 noncirrhotic patients with chronic hepatitis C treated with Viekira Pak [D-O-P/r] with vs without ribavirin for 12 weeks, SVR rates were 99% vs 99% for genotype 1b and 97% vs 90% for genotype 1a; common adverse events were fatigue, headache and nausea while ALT elevations above 5 times ULN occurred in only 4 patients [0.5%]).
Poordad F, Hezode C, Trinh R, Kowdley KV, Zeuzem S, Agarwal K, Shiffman ML, et al. (2014). ABT-450/r-ombitasvir and dasabuvir with ribavirin for hepatitis C with cirrhosis. N Engl J Med. (Among 380 cirrhotic patients with chronic hepatitis C, genotype 1, treated with Viekira Pak [D-O-P/r] with ribavirin for 12 vs 24 weeks, SVR rates were 92% vs 96%; ALT elevations above 5 times ULN occurred in 6 patients [1.6%], one of whom had “acute hepatitis” and discontinued treatment early).
Andreone P, Colombo MG, Enejosa JV, Koksal I, Ferenci P, Maieron A, Müllhaupt B, et al. (2014). ABT-450, ritonavir, ombitasvir, and dasabuvir achieves 97% and 100% sustained virologic response with or without ribavirin in treatment-experienced patients with HCV genotype 1b infection. Gastroenterology. (Among 179 noncirrhotic, previously treated patients with chronic hepatitis C, genotype 1b, treated with Viekira Pak [D-O-P/r] with vs without ribavirin for 12 weeks, SVR rates were 97% vs 100%; significant bilirubin elevations occurred only in those on ribavirin and no patient developed ALT elevations above 5 times ULN).
Kwo PY, Mantry PS, Coakley E, Te HS, Vargas HE, Brown R, Gordon F, et al. (2014). An interferon-free antiviral regimen for HCV after liver transplantation. N Engl J Med. (Among 34 patients with recurrent HCV after liver transplantation who were treated with Viekira Pak [D-O-P/r] and ribavirin for 24 weeks, 97% had an SVR and common adverse events were fatigue, headache, cough and need for cyclosporine dose modification; no patient developed ALT elevations above 5 times ULN).
Liang TJ, Ghany MG. (2014). Therapy of hepatitis C--back to the future. N Engl J Med. (Commentary on the evolving status of therapy of chronic hepatitis C from poorly effective and tolerated interferon based treatments to very effective and well tolerated all-oral regimens that yield response rates of 85% to 100% with 12 to 24 weeks of treatment).
Lawitz E, Sullivan G, Rodriguez-Torres M, Bennett M, Poordad F, Kapoor M, Badri P, et al. (2015). Exploratory trial of ombitasvir and ABT-450/r with or without ribavirin for HCV genotype 1, 2, and 3 infection. J Infect. (Among 61 previously untreated, noncirrhotic patients with chronic hepatitis C treated with ombitasvir and paritaprevir with ritonavir [O-P/r] with or without ribavirin, SVR rates varied by genotype; 2 patients had ALT elevations above 5 times ULN, but were without symptoms or jaundice, and abnormalities resolved upon stopping).
Hézode C, Asselah T, Reddy KR, Hassanein T, Berenguer M, Fleischer-Stepniewska K, Marcellin P, et al. (2015). Ombitasvir plus paritaprevir plus ritonavir with or without ribavirin in treatment-naive and treatment-experienced patients with genotype 4 chronic hepatitis C virus infection(PEARL-I): a randomised, open-label trial. Lancet. (Among 135 patients with chronic hepatitis C, genotype 4, treated with Technive [O-P/r] with vs without ribavirin for 12 weeks, SVR rates were 100% vs 90%, and no patient developed ALT elevations above 5 times ULN or clinically apparent liver injury).
Sulkowski MS, Eron JJ, Wyles D, Trinh R, Lalezari J, Wang C, Slim J, et al. (2015). Ombitasvir, paritaprevir co-dosed with ritonavir, dasabuvir, and ribavirin for hepatitis C in patients co-infected with HIV-1: a randomized trial. JAMA. (Among 63 patients with chronic hepatitis C, genotype 1, and HIV coinfection who were treated with Viekira Pak [D-O-P/r], SVR rates were 94% [12 weeks] and 91% [24 weeks] and no patient had an ALT elevation above 5 times ULN).
Kalafateli M, Dusheiko G, Manousou P. (2015). Clinical decompensation after achieving SVR with sofosbuvir, daclatasvir and ribavirin in a patient with recurrent HCV post-liver transplant. J Gastrointestin Liver Dis. (33 year old male with hemophilia and chronic hepatitis C, genotype 3, underwent liver transplantation and had recurrence of HCV posttransplant, subsequently failing to respond to several interferon based courses of therapy, eventually responding to sofosbuvir, daclatasvir and ribavirin, but then developing hepatic decompensation 2 months after achieving an SVR).
(2015). A 4-drug combination (Viekira Pak) for hepatitis C. Med Lett Drugs Ther. (Concise summary of clinical efficacy, side effects, drug-drug interactions and costs of Viekira Pak [D-O-P/r] for chronic hepatitis C, genotype 1, shortly after its approval in the US mentions that ALT elevations occur in 1-4% of patients and may require early discontinuation, for which reason ALT monitoring is recommended for the first 4 weeks).
Lalezari J, Sullivan JG, Varunok P, Galen E, Kowdley KV, Rustgi V, Aguilar H, et al. (2015). Ombitasvir/ paritaprevir/r and dasabuvir plus ribavirin in HCV genotype 1-infected patients on methadone or buprenorphine. J Hepatol. (Among 38 noncirrhotic patients with chronic hepatitis C, genotype 1, on opioid replacement therapy who were treated with Viekira Pak [D-O-P/r] with ribavirin for 12 weeks, the SVR rate was 97% and no patient had a serious liver related adverse event or stopped therapy because of ALT elevations; ALT results not provided).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 were attributed to antiviral agents, but all were antiretroviral agents and none were oral direct acting agents used to treat chronic hepatitis C).
Bailly F, Pradat P, Virlogeux V, Zoulim F. (2015). Antiviral therapy in patients with hepatitis C virus-induced cirrhosis. Dig Dis. (Review of the status of antiviral therapy of chronic hepatitis C with cirrhosis summarizing the high rate of adverse events, including hepatic decompensation and death with peginterferon based regimens combined with boceprevir or telaprevir, and recommending the use of the more effective and better tolerated all-oral regimens).
Ferenci P, Kozbial K, Mandorfer M, Hofer H. (2015). HCV targeting of patients with cirrhosis. J Hepatol. (Review of the status of antiviral therapy of chronic hepatitis C with cirrhosis, suggests that genotype 1 infected patients should receive an all-oral regimen such as sofosbuvir with ledipasvir or daclatasvir or the triple combination of dasabuvir with ombitasvir and paritaprevir/ritonavir [D-O-P/r], the major issues being duration of therapy and the role of ribavirin).
Feld JJ, Moreno C, Trinh R, Tam E, Bourgeois S, Horsmans Y, Elkhashab M, et al. (2016). Sustained virologic response of 100% in HCV genotype 1b patients with cirrhosis receiving ombitasvir/paritaprevir/r and dasabuvir for 12 weeks. J Hepatol. (Among 60 patients with chronic hepatitis C, genotype 1b, and cirrhosis treated with D-O-P/r for 12 weeks, all achieved an SVR and “laboratory abnormalities were infrequently observed and not clinically significant”; only one patient had a severe adverse event (hypotension and syncope) and 1 had an ALT elevation above 5 times ULN, but on one occasion only, resolving without dose modification).
Klibanov OM, Gale SE, Santevecchi B. (2015). Ombitasvir/paritaprevir/ritonavir and dasabuvir tablets for hepatitis C virus genotype 1 infection. Ann Pharmacother. (Review of the pharmacology, efficacy and safety of D-O-P/r with [genotype 1a] or without [genotype 1b] ribavirin in patients with chronic hepatitis C summarizes adverse event profile in a pooled analysis of 2887 patients, and mentions that ALT elevations are rare [≤1.2%] and that isolated bilirubin elevations occur [≤4.5%], but without concurrent ALT elevations; no mention of hepatic decompensation).
European Association for Study of Liver. (2015). EASL recommendations on treatment of hepatitis C 2015. J Hepatol. (Guidelines for the antiviral therapy of chronic hepatitis C from the European liver disease research and academic society).
AASLD/IDSA HCV Guidance Panel. (2015). Hepatitis C guidance: AASLD-IDSA recommendations for testing, managing, and treating adults infected with hepatitis C virus. Hepatology. (Guidelines for the antiviral therapy of chronic hepatitis C from the US liver and infectious diseases research and academic societies).
Dyson JK, Hutchinson J, Harrison L, Rotimi O, Tiniakos D, Foster GR, Aldersley MA, et al. (2016). Liver toxicity associated with sofosbuvir, an NS5A inhibitor and ribavirin use. J Hepatol. (74 year old man and 36 year old woman with HCV related cirrhosis developed worsening hepatic decompensation within a few weeks of starting sofosbuvir, an NS5A inhibitor and ribavirin [peak bilirubin 23.4 and 30.5 mg/dL, ALT 65 and 96 U/L, Alk P 202 and 398 U/L], resulting in death in one and emergency liver transplant in the other).
Marchan-Lopez A, Dominguez-Dominguez L, Kessler-Saiz P, Jarrin-Estupiñan ME. (2016). Liver failure in human immunodeficiency virus - hepatitis C virus coinfection treated with sofosbuvir, ledipasvir and antiretroviral therapy. J Hepatol. (Letter in response to Dyson [2016]: 49 year old man with chronic hepatitis C, cirrhosis [Child-Pugh class B] and HIV coinfection developed worsening hepatic decompensation 1 to 2 months after starting sofosbuvir and ledipasvir that worsened for two weeks after stopping [peak bilirubin 46.9 mg/dL, INR 3.17], and then resolved; he later tolerated reinitiation of antiretroviral drugs).
Dyson JK, McPherson S. (2016). Reply to "Liver failure in human immunodeficiency virus - Hepatitis C virus coinfection treated with sofosbuvir, ledipasvir and antiretroviral therapy". J Hepatol. (Letter in reply to March-Lopez [2016] reporting another case of hepatic decompensation during sofosbuvir, ledipasvir and ribavirin therapy of a patient hepatitis C, cirrhosis and HIV coinfection, arising within 6 weeks of starting treatment [bilirubin 12.6 mg/dL, protime 17 sec], and leading to successful, emergency liver transplantation).
Welker MW, Luhne S, Lange CM, Vermehren J, Farnik H, Herrmann E, Welzel T, et al. (2016). Lactic acidosis in patients with hepatitis C virus cirrhosis and combined ribavirin/ sofosbuvir treatment. J Hepatol. (Among 35 patients with chronic hepatitis C and advanced fibrosis or cirrhosis treated with sofosbuvir based regimens, 12 [34%] had a serious adverse event and 5 [14%] developed lactic acidosis, largely in those with Child-Pugh class B or C cirrhosis and in the context of hepatic decompensation, 2 of whom died).
Hoofnagle JH. (2016). Hepatic decompensation during direct-acting antiviral therapy of chronic hepatitis C. J Hepatol. (Editorial in response to Welker [2016] discussing the occurrence of unexplained hepatic decompensation during antiviral therapy of hepatitis C and whether these episodes are coincidental, caused by hepatoxicity of the antiviral drugs, or are the paradoxical result of sudden eradication of the chronic viral infection).
Abdulsamad M, Ihimoyan A. (2016). Viekira Pak induced fatal lactic acidosis: a case report of an unusual side effect. Case Reports Hepatol. (69 year old man with HCV related cirrhosis developed lactic acidosis and renal failure 3 days after starting Viekira Pak, dying within a few days of multiorgan failure).
Masetti M, Magalotti D, Martino E, Andreone P, Scuteri A, Zoli M. (2016). A case of acute liver failure during ritonavir-boosted paritaprevir, ombitasvir and dasabuvir therapy in a patient with HCV genotype 1b cirrhosis. J Gastrointestin Liver Dis. (84 year old man with HCV-related cirrhosis developed hepatic decompensation 13 days after starting Viekira Pak for HCV infection with slow and incomplete recovery upon stopping).
Buzas C, Tantau M, Ciobanu L. (2017). Fatal acute liver failure during ritonavir-boosted paritaprevir, ombitasvir and dasabuvir plus ribavirin therapy. J Gastrointestin Liver Dis. (65 year old woman with HCV-related cirrhosis developed hepatic decompensation 3 days after starting Viekira Pak therapy for hepatitis C and died of hepatic failure 19 days later).
Fofiu C, Dobru D, Boeriu A. (2017). Potential pitfalls of Viekira Pak™ therapy in patients with HCV genotype 1b cirrhosis. J Gastrointestin Liver Dis. (60 year old woman with HCV related cirrhosis developed decompensation 6 weeks after starting Viekira Pak for HCV infection [bilirubin rising from 2.1 to 6.8 mg/dL, INR 1.4 to 1.8], resolving slowly after discontinuation of the combination antiviral therapy; role of ritonavir unclear).
Oberg CL, Hiensch RJ, Poor HD. (2017). Ombitasvir-paritaprevir-ritonavir-dasabuvir (Viekira Pak)-induced lactic acidosis. Crit Care Med. (Three patients with HCV related cirrhosis developed severe lactic acidosis within 5-11 days of starting Viekira Pak, 2 responding to intensive care support and one dying within 36 hours with worsening lactic acidemia and shock).
Chamorro-de-Vega E, Gimenez-Manzorro A, Rodriguez-Gonzalez CG, Escudero-Vilaplana V, De Lorenzo-Pinto A, Iglesias-Peinado I, Herranz-Alonso A, et al., GRUviC Study Group. (2018). Twelve weeks of ombitasvir/paritaprevir/r and dasabuvir without ribavirin is effective and safe in the treatment of patients with HCV genotype 1b infection and compensated cirrhosis: results from a real-world cohort study. Expert Opin Drug Saf. (Among 78 patients with chronic hepatitis C, genotype 1b, treated with Viekira Pak for 12 weeks, the SVR rate was 96% and 78% of patients had an adverse event which were mostly mild, but included 1 patient who developed hepatic decompensation at 4 weeks and stopped therapy early).
Isakov V, Paduta D, Viani RM, Enejosa JV, Pasechnikov V, Znoyko O, Ogurtsov P, et al. (2018). Ombitasvir/paritaprevir/ ritonavir + dasabuvir+ribavirin for chronic hepatitis C virus genotype 1b-infected cirrhotics (TURQUOISE-IV). Eur J Gastroenterol Hepatol. (Among 36 patients with chronic hepatitis C [genotype 1b] and cirrhosis treated with Viekira Pak, the SVR rate was 100% and there were no serious adverse events or episodes of hepatic decompensation or rise of ALT above 5 times ULN).
Ascione A, De Luca M, Melazzini M, Montilla S, Trotta MP, Petta S, Puoti M, et al., ABACUS Study Group. (2018). Safety and efficacy of ombitasvir/paritaprevir/ritonavir/dasabuvir plus ribavirin in patients over 65 years with HCV genotype 1 cirrhosis. Infection. (Among 241 Italian patients with chronic hepatitis C, genotype 1, and cirrhosis treated with Viekira Pak with or without ribavirin for 12 to 24 weeks, the SVR rate was 95% and adverse events arose in 31% including 3 patients with hepatic decompensation, two with ascites and 1 with encephalopathy all of whom recovered and had an SVR).
Pariente A, Arpurt JP, Rémy AJ, Rosa-Hézode I, Causse X, Heluwaert F, Macaigne G, et al. (2019). Association nationale des gastroentérologues des hôpitaux (ANGH). Hepatitis C treatment with all-oral direct-acting antivirals: Effectiveness and tolerance in a multicenter, prospective, observational study from French general hospitals (APROVVIE, ANGH). Presse Med. (Among 1123 patients with chronic hepatitis C [half with cirrhosis] treated with various direct acting early, oral, antiviral regimens in 24 French general hospitals, the overall SVR rate was 91% and serious adverse event rate 5.6%, with two deaths due to hepatic decompensation).
Chen CH, Chen CH, Lin CL, Lin CY, Hu TH, Tung SY, Hsieh SY, et al. (2019). Real-world safety and efficacy of paritaprevir/ritonavir/ombitasvir plus dasabuvir ± ribavirin in patients with hepatitis C virus genotype 1 and advanced hepatic fibrosis or compensated cirrhosis: a multicenter pooled analysis. Sci Rep. (Among 898 patients with chronic hepatitis C, genotype 1, treated with Viekira Pak with or without ribavirin for 12 or 24 weeks, the overall SVR rate was 99%, 18 patients [2%] developed hepatic decompensation [usually within 1-4 weeks], 2 had ALT elevations above 10 times ULN, and 8 of 56 [14]} with preexisting HBsAg not on therapy developed reactivation, 2 with accompanying hepatitis).
Ferenci P, Bourgeois S, Buggisch P, Norris S, Curescu M, Larrey D, Marra F, et al. (2019). Real-world safety and effectiveness of ombitasvir/paritaprevir/ritonavir ± dasabuvir ± ribavirin in hepatitis C virus genotype 1- and 4-infected patients with diverse comorbidities and comedications: A pooled analysis of post-marketing observational studies from 13 countries. J Viral Hepat. (Among 3850 patients with chronic hepatitis C [genotypes 1 and 4; 35% with cirrhosis] treated with Viekira Pak with or without ribavirin for 8, 12 or 24 weeks in observational studies from 13 countries, the SVR rate was 96% and adverse event rate 26%, with 3% serious adverse events including 7 cases of hepatic failure, 3 deaths from liver related causes and 17 episodes of ALT elevations above 5 times ULN).
Poordad F, Sedghi S, Pockros PJ, Ravendhran N, Reindollar R, Lucey MR, Epstein M, et al. (2019). Efficacy and safety of ombitasvir/paritaprevir/ritonavir and dasabuvir with low-dose ribavirin in patients with chronic hepatitis C virus genotype 1a infection without cirrhosis. J Viral Hepat. (Among 105 patients with chronic hepatitis C, genotype 1a, without cirrhosis treated with Viekira Pak with low dose ribavirin [600 mg/d] for 12 weeks, the SVR rate was 90% and 73% of patients had an adverse event, 3 of which were severe; ALT elevations above 3 times ULN arose in 2 patients but none had hepatic decompensation or clinically apparent liver injury).
Londoño MC, Riveiro-Barciela M, Ahumada A, Muñoz-Gómez R, Roget M, Devesa-Medina MJ, Serra MÁ, et al. (2019). Effectiveness, safety/tolerability of OBV/PTV/r ± DSV in patients with HCV genotype 1 or 4 with/without HIV-1 co-infection, chronic kidney disease (CKD) stage IIIb-V and dialysis in Spanish clinical practice – Vie-KinD study. PLoS One. (Among 135 patients with chronic hepatitis C [genotypes 1 and 4] and renal dysfunction [78% on dialysis] treated with Viekira Pak or Technive with or without ribavirin in 31 Spanish centers, the SVR rate was 93%, but only 1 patient failed to have a virologic response; the adverse event rate was 47%, 6 patients discontinued therapy because of side effects and 3 died during therapy, one from hepatic failure).
Manuel Sousa J, Vergara M, Pulido F, Sánchez Antolín G, Hijona L, Carnicer F, Rincón D, et al. (2019). Real-world evidence of the effectiveness of ombitasvir-paritaprevir/r ± dasabuvir ± ribavirin in patients monoinfected with chronic hepatitis C or coinfected with human immunodeficiency virus-1 in Spain. PLoS One. (Among 2408 patients with chronic hepatitis C [genotypes 1 and 4] with [n=386] or without HIV infection treated with Viekira Pak with or without ribavirin for 12 or 24 weeks at 61 Spanish sites, the SVR rate was 95% in those with HIV infection and 97% in those without, while adverse events arose in 25% overall which were serious in only 2%; no mention of acute liver injury or hepatic decompensation).
Poordad F, Castro RE, Asatryan A, Aguilar H, Cacoub P, Dieterich D, Marinho RT, et al. (2020). Long-term safety and efficacy results in hepatitis C virus genotype 1-infected patients receiving ombitasvir/paritaprevir/ritonavir and dasabuvir ± ribavirin in the TOPAZ-I and TOPAZ-II trials. J Viral Hepat. (Among 2211 patients with chronic hepatitis C genotype 1 treated successfully with Viekira Pak and enrolled in 2 long term follow up studies, SVR was maintained in more than 99% for up to 3 years and there was a decrease in mean Fib-4 scores, and mean increases in platelet count and serum albumin levels; among 354 with cirrhosis 7 patients had an episode of decompensation, 5 liver cancer, and 2 liver transplant, but only one suffered a liver related death).
Değertekin B, Demir M, Akarca US, Kani HT, Üçbilek E, Yıldırım E, Güzelbulut F, et al. (2020). Real-world efficacy and safety of Ledipasvir + Sofosbuvir and Ombitasvir/Paritaprevir/Ritonavir ± Dasabuvir combination therapies for chronic hepatitis C: A Turkish experience. Turk J Gastroenterol. (Among 4352 patients with chronic hepatitis C treated with Viekira Pak or Harvoni with or without ribavirin for 12 or 24 weeks at 36 medical centers in Turkey, the SVR rate was 93% and was similar with all regimens, while adverse events were reported in 19% of patients, but there were no treatment related serious adverse events, although there were 3 liver-related deaths).
Hung HY, Chen CY, Liao YH. (2021). A retrospective cohort study: safety and effectiveness of elbasvir/grazoprevir ± ribavirin compared with ombitasvir/paritaprevir/ritonavir/dasabuvir ± ribavirin in patients with chronic hepatitis C genotype 1 infection. Front Pharmacol. (Among 254 patients with chronic hepatitis C, genotype 1, treated with Mavyret or Viekira Pak with or without ribavirin for 12 or 24 weeks, the SVR rate was similar in the two groups while ALT elevations above 5 times ULN arose in 4 of 105 receiving Mavyret vs 2 of 149 on Viekira Pak).
Torgersen J, Newcomb CW, Carbonari DM, Rentsch CT, Park LS, Mezochow A, Mehta RL, et al. (2021). Protease inhibitor-based direct-acting antivirals are associated with increased risk of aminotransferase elevations but not hepatic dysfunction or decompensation. J Hepatol. (Among propensity matched subgroups of 71,391 adults with chronic hepatitis C treated in the Veterans Administration Medical system with oral, direct acting antiviral agents, patients with higher baseline fibrosis scores compared to those with lower scores were more likely to have serum ALT elevations [>200 U/L] [0.5% vs 0.3%] and hepatic decompensation [0.41% vs 0.03%], and ALT elevations were more frequent with Viekira Pak and Technive [1.1-1.2%] compared to Mavyret, Zepatier, Epclusa, and Harvoni [0.11-0.39%]).

## OTHER REFERENCE LINKS

1 Recent References on Viekira Pak: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Viekira%20Pak/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Viekira Pak: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Viekira%20Pak)